# Risdiplam

## OVERVIEW

### Introduction

Risdiplam is a small molecular modifier of RNA splicing of survival motor neuron 2 protein used in the therapy of spinal muscular atrophy, a rare progressive neuromuscular disorder that typically leads to disability and death within the first two years of life. Risdiplam is given orally once daily and has not been linked to serum aminotransferase or bilirubin elevations during therapy nor to instances of clinically apparent liver injury.

### Background

Risdiplam (ris dip’ lam) is a small molecule modifier of RNA splicing of survival motor neuron 2 protein which can partially correct the gene defect of spinal muscular atrophy (SMA), a rare inherited disease that results in progressive neuromuscular disability leading to severe muscle weakness, paralysis, need for ventilatory support, and death usually within the first two years of life. The disease is due to a genetic deficiency in survival motor neuron (SMN) protein caused by a bi-allelic loss-of-function mutation in the SMN1 gene which is critical for motor neuron survival. The severity of SMA varies based upon the activity and number of copies of the SMN2 gene, which ordinarily contributes only a small proportion of needed SMN activity because of the unstable protein variant that it encodes. Despite this limitation, SMN2 expression can partially compensate for the reduction of SMN activity in patients with SMA, particularly if the SMN2 gene is present in more than 2 copies. Risdiplam modifies the RNA splicing of SMN2 allowing for an increase in its production. In pilot studies, daily therapy of risdiplam led to better maintenance of motor function and improved survival without ventilatory support in infants with SMA type 1 in comparison to historical controls beyond the ages predicted by natural history studies of this ordinarily fatal genetic disorder. In patients with late onset SMA types 2 and 3, risdiplam resulted in improvements in motor function in comparison to placebo. Risdiplam was approved for use in the United States in 2020 for infants (above the age of 2 months) and adults with genetically proven SMA. Risdiplam is available as a powder for reconstitution under the brand name Evrysdi. The recommended dose is 5 mg daily in adults and children 2 years of age or older who weigh 20 kg or more. The dose is lower in children less than 2 years of age and older children who weigh less than 20 kg. Risdiplam is generally well tolerated. Adverse events can include fever, symptoms of upper respiratory syndrome, constipation, diarrhea, rash, nausea, vomiting and arthralgia. More severe adverse events identified in preregistration trials included pneumonia, hypoxia, and fever, which are well known complications of SMA and may not have been due to risdiplam. Two other drugs are approved for treatment of SMA: nusinersen, an antisense oligonucleotide approved for children and adults which was approved in 2016; and onasemnogene abeparvovec, an adeno-associated virus vector-based gene therapy approved in 2019 for children under the age of 2 years. These two agents require parenteral administration and are less well tolerated than risdiplam.

### Hepatotoxicity

In preregistration clinical trials, there were no clinically significant changes in serum laboratory values with risdiplam therapy and no differences in serum ALT, AST, and bilirubin values between risdiplam vs placebo recipients. While safety results were based on only several hundred patients, there were no cases of suspected drug induced liver injury with jaundice. Furthermore, there have been no published cases of clinically apparent liver injury attributed to risdiplam since its approval in 2020.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which risdiplam might cause liver injury is unknown. The molecule also modifies RNA splicing in other genes which might have an effect on liver function or homeostasis.

Drug Class: Genetic Disorder Agents

Other Agents for SMA: Nusinersen, Onasemnogene Abeparvovec

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Risdiplam – Evrysdi®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Risdiplam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Risdiplam | 1825352-65-5 | C22-H23-N7-O

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2024

Abbreviations: SMA, spinal muscular atrophy; SMN, survival motor neuron.

FDA. 2020. Clinical Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213535Orig1s000MedR.pdf (FDA website with product label and clinical review of the data on efficacy and safety of risdiplam in support of its approval as therapy of spinal muscular atrophy mentions that “there were no clinically significant differences in key blood chemistry parameters between the placebo and risdiplam groups” including ALT, AST, and bilirubin values and no instance of clinically apparent liver injury with jaundice).
Kolb SJ, Coffey CS, Yankey JW, Krosschell K, Arnold WD, Rutkove SB, Swoboda KJ, et al.; NeuroNEXT Clinical Trial Network on behalf of the NN101 SMA Biomarker Investigators. Natural history of infantile-onset spinal muscular atrophy. Ann Neurol 2017; 82: 883-91. (Natural history study of 26 infants with SMA1 demonstrating the rate of motor function deterioration, respiratory failure, and survival in untreated infants). 29149772
Ratni H, Ebeling M, Baird J, Bendels S, Bylund J, Chen KS, Denk N, et al. Discovery of risdiplam, a selective survival of motor neuron-2 (SMN2) gene splicing modifier for the treatment of spinal muscular atrophy (SMA). J Med Chem. 2018;61:6501-6517. (Description of the development of risdiplam, the optimization of its efficacy in splice modification of SMN2 with minimalization of its modification of mRNAs of other important proteins [FOXM1] and improvement in pharmacokinetics and safety in preclinical studies). 30044619
Stevens D, Claborn MK, Gildon BL, Kessler TL, Walker C. Onasemnogene abeparvovec-xioi: gene therapy for spinal muscular atrophy. Ann Pharmacother 2020; 54: 1001-9. (Review of the mechanism of action, clinical efficacy and safety of onasemnogene abeparvovec mentions that two treatment related serious adverse events occurred in the initial trial, elevations in serum ALT levels of 14 and 31 times upper limit of normal that resolved with corticosteroid therapy; no further hepatic adverse events being reported in clinical trials and registration studies, although the product has a black box warning about liver injury and prophylactic corticosteroids are recommended). 32204605
Dhillon S. Risdiplam: first approval. Drugs. 2020;80:1853-1858. (Summary of the chemical structure, mechanism of action, history of development, pharmacology, clinical efficacy, and safety of risdiplam shortly after its approval in the US, does not mention ALT elevations or hepatotoxicity). 33044711
Baranello G, Darras BT, Day JW, Deconinck N, Klein A, Masson R, Mercuri E, et al.; FIREFISH Working Group. Risdiplam in type 1 spinal muscular atrophy. N Engl J Med. 2021;384:915-923. (Among 21 infants with SMA1 treated with high or low doses of risdiplam, serum SMN levels increased in both groups and event-free survival appeared to be better than expected from historical controls and while adverse events were frequent, they were largely those expected in infants with SMA1, and “laboratory results…did not show clinically significant adverse findings”). 33626251
Darras BT, Masson R, Mazurkiewicz-Bełdzińska M, Rose K, Xiong H, Zanoteli E, Baranello G, et al.; FIREFISH Working Group. Risdiplam-treated infants with type 1 spinal muscular atrophy versus historical controls. N Engl J Med. 2021;385:427-435. (Among 41 infants with SMA1 treated with risdiplam for at least 12 months, the outcome of ability to sit without support for at least 5 seconds was maintained at a higher rate compared to historical controls [29% vs 5%] and while adverse events were frequent, they were largely those expected in infants with SMA1, and “laboratory results…did not show clinically significant adverse findings”). 34320287
Mercuri E, Deconinck N, Mazzone ES, Nascimento A, Oskoui M, Saito K, Vuillerot C, et al.; SUNFISH Study Group. Safety and efficacy of once-daily risdiplam in type 2 and non-ambulant type 3 spinal muscular atrophy (SUNFISH part 2): a phase 3, double-blind, randomised, placebo-controlled trial. Lancet Neurol. 2022;21:42-52. (Among 180 patients with SMA types 2 and 3 treated with risdiplam or placebo orally once daily for 12 months, motor function measures improved with risdiplam but not placebo, while adverse events more frequent with risdiplam included fever [21% vs 17%], diarrhea [17% vs 8%], rash [17% vs 2%], mouth ulcers [7% vs 0%], urinary tract infections [7% vs 0%], and arthralgia [5% vs 0], but no patient stopped therapy for adverse events and there were no severe hepatic adverse events). 34942136
Cances C, Vlodavets D, Comi GP, Masson R, Mazurkiewicz-Bełdzińska M, Saito K, Zanoteli E, et al.; ANCHOVY Working Group. Natural history of type 1 spinal muscular atrophy: a retrospective, global, multicenter study. Orphanet J Rare Dis. 2022;17:300. (Among 60 patients with type 1 SMA enrolled in a multinational chart review, the median age of symptom onset was 1.6 months, median age for reaching death or permanent ventilatory support was 7.3 months, and no child could sit without support at 12 months; these historical results were important for assessing results of therapy in small uncontrolled trials of new therapies such as risdiplam). 35906608
Masson R, Mazurkiewicz-Bełdzińska M, Rose K, Servais L, Xiong H, Zanoteli E, Baranello G, et al.; FIREFISH Study Group. Safety and efficacy of risdiplam in patients with type 1 spinal muscular atrophy (FIREFISH part 2): secondary analyses from an open-label trial. Lancet Neurol. 2022;21:1110-1119. (Among 41 infants with type 1 SMA treated with risdiplam [Baranello 2021], further follow up to 24 months showed maintenance of improvements with 83% event-free survival although no infant was able stand or walk alone; no adverse event required discontinuation and “all available safety laboratory results… did not show any clinically significant adverse findings”). 36244364
Paik J. Risdiplam: a review in spinal muscular atrophy. CNS Drugs. 2022;36:401-410. (Review of the mechanism of action, pharmacology, and efficacy of risdiplam in SMA type 1 and SMA types 2 and 3, and its current status as therapy of SMA; no mention of ALT elevations or hepatotoxicity). 35284988
Yu L, Liu L. Exploration of adverse events associated with risdiplam use: Retrospective cases from the US Food and Drug Administration Adverse Event Reporting System (FAERS) database. PLoS One. 2024;19:e0298609. (Analysis of FDA Adverse Event Reporting System [FAERS] on risdiplam between 2020 and 2023 identified 1588 reports, 0.5% of which were hepatobiliary, mostly liver enzyme elevations, specifics not provided). 38427665
Chiriboga CA, Bruno C, Duong T, Fischer D, Mercuri E, Kirschner J, Kostera-Pruszczyk A, et al.; JEWELFISH Study Group. JEWELFISH: 24-month results from an open-label study in non-treatment-naïve patients with SMA receiving treatment with risdiplam. J Neurol. 2024;271:4871-4884. (Among 173 patients with SMA previously treated with nusinersen, olesoxime, or onasemnogene who were treated with open label risdiplam and followed for a median of 27 months, motor function was maintained and SMN levels rose in all groups, while adverse events included fever, diarrhea, headache, and upper respiratory infections, but “a review of all available safety laboratory results …. did not show any clinically significant adverse findings compared to baseline”). 38733387

## OTHER REFERENCE LINKS

1. Recent References on Risdiplam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Onasemnogene+AND+Risdiplam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Risdiplam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Onasemnogene%20Risdiplam)

Sponsors: PTC Therapeutics, SMA Foundation, Genentech, Roche